# Sotalol

## OVERVIEW

### Introduction

Sotalol is a nonselective beta-adrenergic blocker used largely in the therapy cardiac arrhythmias. Sotalol has been linked to at least one instance of clinically apparent liver injury.

### Background

Sotalol (soe' ta lol) is a nonselective beta-blocker, acting on both beta-1 and beta-2 adrenergic receptors. Beta-1 adrenergic blockade reduces the heart rate and myocardial contractility by slowing the AV conduction and suppressing automaticity. Beta-2 blockade affects peripheral vascular resistance and can also cause bronchospasm and hypoglycemia. In addition, sotalol has unique antiarrhythmic activity not shared by all beta-blockers. Sotalol is indicated for the management of atrial and ventricular arrhythmias. While it has antihypertensive effects, sotalol is not generally used for treatment of hypertension alone. Sotalol was approved for use in the United States in 1992 and its current indications include maintenance of normal sinus rhythm in patients with symptomatic atrial fibrillation and treatment of severe or life-threatening ventricular arrhythmias. Sotalol is available in tablets of 80, 120, 160 and 240 mg in generic forms and under the trade names Betapace, Betapace AF and Sorine. The typical initial dose of sotalol in adults is 80 mg twice daily, with subsequent dose adjustment based upon clinical response and tolerance, the typical maintenance dose being 160 to 320 mg daily. Common side effects of sotalol include bradycardia, hypotension, fatigue, dizziness, depression, memory loss, impotence, cold limbs and, less commonly, severe hypotension, heart failure and bronchospasm. Sudden withdrawal can trigger rebound hypertension. Beta-blockers are contraindicated in patients with asthma, bradycardia and heart failure and should be used cautiously in the elderly and in patients with diabetes.

### Hepatotoxicity

Mild-to-moderate elevations in serum aminotransferase levels occur in less than 2% of patients on sotalol and are usually transient and asymptomatic, resolving even with continuation of therapy. Sotalol has been linked to a single case of clinically apparent liver injury, with onset of an acute hepatitis-like syndrome with prolonged jaundice 12 weeks after sotalol was initiated. The injury improved but did not resolve with discontinuation of sotalol. In large case series of drug induced liver disease and acute liver failure, sotalol has not been listed as a cause. Other beta-blockers have been linked to rare instances of acute clinically apparent liver injury with a latency to onset ranging from 4 to 24 weeks, a hepatocellular pattern of serum enzyme elevations and a mild, self-limiting course without evidence of hypersensitivity or autoimmune reactions.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Sotalol undergoes minimal metabolism by the liver and is excreted largely unchanged in the urine. The reason why sotalol might cause liver injury is unknown. The acute liver injury attributed to other beta-blockers is likely to be idiosyncratic.

References to the safety and potential hepatotoxicity of sotalol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sotalol – Generic, Betapace®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sotalol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sotalol | 3930-20-9 | C12-H20-N2-O3-S | Sotalol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Sotalol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Sotalol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sotalol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sotalol)